# Bile Acids

## OVERVIEW

### Introduction

Bile acids are a large family of molecules that have a steroidal structure and are synthesized from cholesterol in the liver and actively secreted along with cholesterol and phospholipids into the bile. Bile flowing from the liver is concentrated in the gallbladder and, in response to a meal, released into the upper intestine. In the intestines, bile acids act as detergents and help to emulsify fats, aiding in their digestion and absorption. After participating in digestion in the small bowel, bile acids are almost completely (95%) reabsorbed in the distal ileum and then retaken up from portal blood by the liver (enterohepatic circulation). The primary bile acids synthesized in the liver are cholic and chenodeoxycholic acid which are typically conjugated to glycine or taurine before secretion. In the intestine, the primary bile acids are often converted by colonic bacteria to the secondary bile acids, predominantly deoxycholic acid and lithocholic acid. The reabsorbed bile acids are transported to the liver in portal blood. Conjugated bile acids are then retaken up by hepatocytes via the sodium taurocholate cotransporter (NTCT), while unconjugated bile acids are taken up by organic anion transporters that also take up bilirubin and other anions. The total bile acid pool in humans is tightly controlled by a coordinated regulation of expression of genes involved with synthesis, secretion, reabsorption and reuptake of bile acids by the liver. The major components of the bile acid pool are cholic and chenodeoxycholic acid with lesser amounts deoxycholic and lithocholic acid and minor amounts of ursodeoxycholic acid.

Bile acids also act as signaling molecules and are important in regulation of their own synthesis, uptake and secretion as well as control of cholesterol synthesis and regulation of lipid and glucose metabolism. Bile acid levels are increased in the serum and liver in patients with obstructive jaundice or cholestasis and, perhaps because of their inherent detergent activities, can cause hepatocyte injury. Thus, increased bile acid levels in hepatocytes may account for some of the liver damage in cholestatic liver diseases.

Bile acids can be used as therapeutic agents, particularly in patients with cholestatic liver diseases where administered bile acids (such as ursodeoxycholic acid) replace the more lipophilic and toxic bile acids that accumulate during cholestasis. Bile acids are also useful for the medical treatment (dissolution) of gallstones by increasing bile acid and decreasing cholesterol concentrations in bile (causing a less saturated bile). Bile acids can also be useful as replacement therapy in patients with bile acid synthetic defects. Finally, the other metabolic effects of bile acids can be useful in treating metabolic diseases including nonalcoholic steatohepatitis. Four bile acids are currently approved for use in the United States and several others are under active investigation. Cholic acid is used for treatment of inherited defects in bile acid synthesis, chenodeoxycholic (chenodiol) and ursodeoxycholic (ursodiol) acid for gallstone dissolution, and obeticholic and ursodiol for chronic cholestatic liver diseases, specifically primary biliary cirrhosis. Obeticholic acid is under evaluation as therapy of other liver diseases including sclerosing cholangitis and nonalcoholic steatohepatitis. Ursodiol is used off label to prevent, treat or ameliorate several uncommon forms of liver disease, including intrahepatic cholestasis of pregnancy, sinusoidal obstruction syndrome, graft-vs-host disease, cystic fibrosis associated liver disease, parenteral nutrition related liver injury and even acute, drug induced liver injury. The long term efficacy in ameliorating the course of these diseases is, however, unproven.

Separate documents are available in LiverTox for each of the currently available bile acids. References given in this overview section are limited to general publications on bile acid metabolism and use as therapeutic agents.

Drug Class: Gastrointestinal Agents

- Chenodiol (Chenodeoxycholic Acid)
- Cholic Acid
- Obeticholic Acid
- Ursodiol (Ursodeoxycholic Acid)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chenodiol – Generic, Chenodal®

Cholic Acid – Cholbam®

Obeticholic Acid – Ocaliva®

Ursodiol – Generic, Actigall®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bile+Acids)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chenodiol | 474-25-9 | C24-H40-O4 | Bile Acids Chemical Structure
Cholic Acid | 81-25-4 | C24-H40-O5 | Bile Acids Chemical Structure
Obeticholic Acid | 459789-99-2 | C26-H44-O4 | Bile Acids Chemical Structure
Ursodiol | 128-13-2 | C24-H40-O4 | Bile Acids Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2017

Abbreviations used: NASH, nonalcoholic steatohepatitis; PBC, primary biliary cholangitis; PSC, primary sclerosing cholangitis.

Zimmerman HJ. Bile acid derivatives. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999; mentions that chenodiol led to aminotransferase elevations in 30-50% of treated patients and at least 4 instances of overt hepatitis occurred in recipients, but it has been largely replaced by ursodiol which has been associated with only “trivial” elevations in ALT levels).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Thistle JL, Hofmann AF. Efficacy and specificity of chenodeoxycholic acid therapy for dissolving gallstones. N Engl J Med 1973; 289: 655-9. (Among 53 patients with radiolucent gallstones treated with chenodiol, cholic acid or placebo for 6 months, stone size decreased in 61% of chenodiol but in none of the cholic acid or placebo recipients; AST elevations above twice ULN occurred in 29% of patients, but levels returned to normal despite continuing treatment). 4580472
Hofmann AF, Thistle JL, Klein PD, Szczepanik PA, Yu PY. Chenotherapy for gallstone dissolution. II. Induced changes in bile composition and gallstone response. JAMA 1978; 239: 1138-44. (Chenodiol but not cholic acid or placebo therapy was associated with disease in cholesterol saturation of bile; the amount of change, however, did not correlate with success of therapy in dissolving gallstones). 628065
Thistle JL, Hofmann AF, Ott BJ, Stephens DH. Chenotherapy for gallstone dissolution. I. Efficacy and safety. JAMA 1978; 239: 1041-6. (Among 90 patients with radiolucent gallstones treated with chenodiol, response rates increased with time, with higher doses and smaller stones; mild elevations in AST occurred in 16% of patients but were transient, resolving with dose modification and not associated with jaundice or symptoms). 342729
Schoenfield LJ, Lachin JM. Chenodiol(chenodeoxycholic acid) for dissolution of gallstones: the National Cooperative Gallstone Study. A controlled trial of efficacy and safety. Ann Intern Med 1981; 95; 257-82. (Among 916 patients with radiolucent gallstones treated with chenodiol [350 or 750 mg daily] vs placebo for 2 years, gallstone dissolution occurred in 5% and 13.5% vs 0% and ALT elevations in 13% to 19% vs 13% which were above 3 times ULN in 5% to 8% vs 4% while biopsies showed nonspecific changes only; ALT elevations resolved even without stopping in most and among 17 who stopped therapy, 6 had recurrence on restarting; no patient developed clinically apparent liver injury). 7023307
Miyai K, Javitt NB, Gochman N, Jones HM, Baker D. Hepatotoxicity of bile acids in rabbits: ursodeoxycholic acid is less toxic than chenodeoxycholic acid. Lab Invest 1982; 46: 428-37. (Feeding rabbits chenodeoxycholic and lithocholic acid led to increases in ALT levels, histologic changes in the liver and significant mortality compared to no treatment or use of ursodiol). 7200166
Roda E, Bazzoli F, Labate AM, Mazzella G, Roda A, Sama C, Festi D, et al. Ursodeoxycholic acid vs. chenodeoxycholic acid as cholesterol gallstone-dissolving agents: a comparative randomized study. Hepatology 1982; 2: 804-10. (Among 223 patients with gallstones treated with ursodiol or chenodiol at 2 doses for 12 months, rates of gallstone dissolution were similar at the higher doses but greater for ursodiol at the lower doses; ALT elevations occurred only in chenodiol groups [14%], but there were no concurrent elevations in Alk P or bilirubin). 7141392
Erlinger S, Le Go A, Husson JM, Fevery J. Franco-Belgian cooperative study of ursodeoxycholic acid in the medical dissolution of gallstones: a double-blind, randomized, dose-response study, and comparison with chenodeoxycholic acid. Hepatology 1984; 4: 308-14. (Among 197 patients with radiolucent gallstones treated with ursodiol or chenodiol, stone dissolution rates were similar and diarrhea was less with ursodiol [5% vs 23%], and ALT elevations were transient and mild [less than twice normal] in all except one patient [3%] on chenodiol). 6706305
Poupon RE, Balkau B, Eschwège E, Poupon R. A multicenter, controlled trial of ursodiol for the treatment of primary biliary cirrhosis. UDCA-PBC Study Group. N Engl J Med 1991; 324: 1548-54. (Among 146 patients with PBC treated with ursodiol [13-15 mg daily] or placebo for 2 years, ALT, Alk P and bilirubin levels and liver histology [except for fibrosis] improved with ursodiol but not placebo; one patient on ursodiol required discontinuation because of worsening of pruritus; no mention of hepatotoxicity or other toxicities). 1674105
Daugherty CC, Setchell KD, Heubi JE, Balistreri WF. Resolution of liver biopsy alterations in three siblings with bile acid treatment of an inborn error of bile acid metabolism(delta 4-3-oxosteroid 5 beta-reductase deficiency). Hepatology 1993; 18: 1096-101. (Among 3 siblings with a bile acid synthetic defect and severe liver disease, treatment with cholic acid and ursodiol was followed by resolution of jaundice and improvements in ALT, Alk P and liver histology). 8225213
Heathcote EJ, Cauch-Dudek K, Walker V, Bailey RJ, Blendis LM, Ghent CN, Michieletti P, et al. The Canadian Multicenter Double-blind Randomized Controlled Trial of ursodeoxycholic acid in primary biliary cirrhosis. Hepatology 1994; 19: 1149-56. (Among 222 patients with PBC treated with ursodiol [14 mg/kg daily] or placebo for 24 months, ALT, Alk P and bilirubin levels and some features of histology [not fibrosis] improved with ursodiol therapy, but symptoms did not change and there were no differences in rates of death or liver transplantation; no mention of hepatotoxicity). 8175136
Lindor KD, Dickson ER, Baldus WP, Jorgensen RA, Ludwig J, Murtaugh PA, Harrison JM, et al. Ursodeoxycholic acid in the treatment of primary biliary cirrhosis. Gastroenterology 1994; 106: 1284-90. (Among 180 patients with PBC treated with ursodiol [13-15 mg/kg daily] or placebo for up to 4 years, there were improvements in Alk P, ALT, AST and bilirubin with ursodiol, but no significant change in liver histology or symptoms and a non-significant decrease in liver transplantation and mortality; no mention of ALT elevations or hepatotoxicity). 8174890
Combes B, Carithers RL Jr, Maddrey WC, Lin D, McDonald MF, Wheeler DE, Eigenbrodt EH, et al. A randomized, double-blind, placebo-controlled trial of ursodeoxycholic acid in primary biliary cirrhosis. Hepatology 1995; 22: 759-66. (Among 151 patients with PBC treated with ursodiol [10-12 mg/kg] or placebo for 2 years, decreases in bilirubin, ALT and Alk P as well as histological features improved mostly in patients with earlier stage disease, but there was no overall effect on rates of mortality or liver transplantation). 7657280
Colombo C, Battezzati PM, Podda M, Bettinardi N, Giunta A. Ursodeoxycholic acid for liver disease associated with cystic fibrosis: a double-blind multicenter trial. The Italian Group for the Study of Ursodeoxycholic Acid in Cystic Fibrosis. Hepatology 1996; 23: 1484-90. (Among 55 patients with cystic fibrosis with liver disease treated with ursodiol [15 mg/kg daily], taurine, both or placebo, GGT, ALT and AST levels improved more in ursodiol treated patients and “no severe side effects were reported”, although one ursodiol treated patient developed jaundice and decompensation after 7 months and was withdrawn and underwent liver transplantation). 8675168
Hempfling W, Dilger K, Beuers U. Systematic review: ursodeoxycholic acid--adverse effects and drug interactions. Aliment Pharmacol Ther 2003; 18: 963-72. (Systematic review of side effects of ursodiol mentions that no severe adverse events or liver toxicities were reported in controlled clinical trials for gallstones or chronic cholestatic liver diseases, but instances of clinical decompensation were reported in patients with preexisting cirrhosis, suggesting that it should be used with caution in patients with advanced disease). 14616161
Bove KE, Heubi JE, Balistreri WF, Setchell KD. Bile acid synthetic defects and liver disease: a comprehensive review. Pediatr Dev Pathol 2004; 7: 315-34. (Extensive review of the inherited forms of defective bile acid synthesis which are often accompanied by progressive cholestatic liver injury some of which respond to treatment with oral bile acids, including 3β-OH steroid dehydrogenase, 5β-reductase and mitochondrial C-27 hydroxylase deficiencies as well as several peroxisomal defects [Zellweger syndrome]). 15383928
Paumgartner G. Medical treatment of cholestatic liver diseases: From pathobiology to pharmacological targets. World J Gastroenterol 2006; 12: 4445-51. (Review of the pathogenesis of gallstone formation and medical therapies for gallstone dissolution). 16874853
Chiang JY. Bile acids: regulation of synthesis. J Lipid Res 2009; 50: 1955-66. (Review of the pathways of cholic and chenodeoxycholic acid synthesis and their regulation via FXR, FGF19, FGFR4 and CYP7A1). 19346330
Gonzales E, Gerhardt MF, Fabre M, Setchell KD, Davit-Spraul A, Vincent I, Heubi JE, et al. Oral cholic acid for hereditary defects of primary bile acid synthesis: a safe and effective long-term therapy. Gastroenterology 2009; 137: 1310-1320. (Among 15 patients with bile acid synthesis defects treated with oral bile acids [ursodiol and cholic acid initially and eventually cholic acid alone for all except one patient: 3-9 mg/kg daily] for 5-15 years, all had lasting clinical improvements shown by repeat liver biopsies in 14; overdose of cholic acid was marked by diarrhea, pruritus and increases in GGT and ALT that responded to dose modification). 19622360
Lindor KD, Kowdley KV, Luketic VA, Harrison ME, McCashland T, Befeler AS, Harnois D, et al. High-dose ursodeoxycholic acid for the treatment of primary sclerosing cholangitis. Hepatology 2009; 50: 808-14. (Among 150 patients with sclerosing cholangitis treated with ursodiol [high doses: 28-30 mg/kg daily] or placebo for up to 5 years, improvements in ALT, Alk P and bilirubin were more common with ursodiol, but so were serious adverse events and clinical outcomes [death, liver transplantation and complications of cirrhosis]). 19585548
Song P, Zhang Y, Klaassen CD. Dose-response of five bile acids on serum and liver bile acid concentrations and hepatotoxicty in mice. Toxicol Sci 2011; 123: 359-67. (Feeding of various concentrations of 5 different bile acids to mice demonstrated clear toxicity with lithocholic, cholic, deoxycholic and chenodeoxycholic acid, but little or no toxicity with ursodeoxycholic acid). 21747115
Joutsiniemi T, Timonen S, Leino R, Palo P, Ekblad U. Ursodeoxycholic acid in the treatment of intrahepatic cholestasis of pregnancy: a randomized controlled trial. Arch Gynecol Obstet 2014; 289: 541-7. (Among 20 pregnant women with intrahepatic cholestasis of pregnancy treated with ursodiol [45 mg daily] or placebo for 14 days, itching scores and serum levels of ALT and bilirubin improved more with ursodiol than placebo treatment). 23978872
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to ursodiol or other bile acid therapies). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Bile Acids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Bile+Acids/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bile Acids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bile+Acids)